# Acalabrutinib

## OVERVIEW

### Introduction

Acalabrutinib is an oral inhibitor of Bruton’s tyrosine kinase that is used in the therapy of B cell malignancies including refractory mantle cell lymphoma and chronic lymphocytic leukemia. Acalabrutinib has been associated with mild-to-moderate serum enzyme elevations during therapy but has not been linked to instances of idiosyncratic acute liver injury, although it has been associated with cases of reactivation of hepatitis B which can be severe and even fatal.

### Background

Acalabrutinib (a kal" a broo' ti nib) is an orally available, small molecule inhibitor of Bruton’s tyrosine kinase (BTK), which is an essential component in the B cell receptor signaling pathway. Inhibition of this pathway prevents B cell activation, differentiation and proliferation. Deficiency of BTK is the cause of X linked (Bruton’s) agammaglobulinemia, and B cell receptor signaling through BTK has been shown to be critical for proliferation and survival of malignant B lymphocytes in mantle cell lymphoma and chronic lymphocytic leukemia (CLL). Unlike ibrutinib, another BTK inhibitor, acalabrutinib has a high degree of specificity for BTK and has little or no activity against other tyrosine kinases. Acalabrutinib was approved for use in the United States as therapy for refractory mantle cell lymphoma in 2017 and for CLL and small lymphocytic lymphoma in 2019. It is under evaluation in other malignancies such as Waldenstrӧm’s macroglobulinemia, pancreatic and non-small cell lung cancer. Acalabrutinib is available in capsules of 100 mg under the brand name Calquence. The recommended dose is 100 mg twice daily. Side effects are common, but usually mild-to-moderate in severity; they include myelosuppression, fatigue, diarrhea, nausea, headache, arthralgia, myalgia, bruising and rash. Uncommon, but potentially serious side effects include severe bone marrow suppression, severe or opportunistic infections, bleeding episodes, hypertension, cardiac arrhythmias and secondary malignancies.

### Hepatotoxicity

In open label clinical trials of acalabrutinib in patients with CLL and mantle cell lymphoma, serum aminotransferase elevations occurred in 19% to 23% of patients during therapy and rose to above 5 times ULN in 2% to 3%. These elevations were transient and resolved spontaneously but occasionally led to early drug discontinuation. Among the 610 patients treated with acalabrutinib in pre-registration trials, there were no instances of clinically apparent liver injury attributed to its use, but there was a single instance of acute liver failure and death due to reactivation of hepatitis B. Similar cases of reactivation have been reported with ibrutinib, another small molecule inhibitor of Bruton's tyrosine kinase. Experience with acalabrutinib has been limited and the frequency of clinically apparent liver injury and reactivation of hepatitis B are not known. The majority of cases have occurred in patients taking multiple immunosuppressive agents and not just acalabrutinib alone.

Likelihood score: D (possible rare cause of reactivation of hepatitis B).

### Mechanism of Injury

The mechanism by which acalabrutinib might cause liver injury is unknown but may be due to off-target inhibition of tyrosine kinases. Acalabrutinib is metabolized in the liver largely by the CYP 3A4 and is susceptible to drug-drug interactions with inhibitors or inducers of this enzyme reactivity. Reactivation of hepatitis B from acalabrutinib is probably the result of profound B cell suppression, which can lead to increases in viral replication, which can result in severe hepatitis upon immune reconstitution.

### Outcome and Management

Liver injury due to acalabrutinib is generally mild and asymptomatic. Reactivation of hepatitis B, however, can result in severe hepatitis and even acute hepatic failure. Patients who are to receive B cell inhibitors such as acalabrutinib, ibrutinib, rituximab and usteokinumab should be screened for serologic markers of hepatitis B infection, including HBsAg and anti-HBc before starting chemotherapy, and those who are positive given prophylaxis against reactivation using oral antiviral agent with activity against HBV such as tenofovir or entecavir. Alternatively, patients can be monitored carefully for changes in HBV DNA levels during therapy. If HBV DNA levels appear de novo or increase significantly (by 10-fold or greater; at least one log increase in HBV DNA), initiation of antiviral therapy is appropriate. Therapy should be continued for at least six months after immunosuppressive therapy has been completed.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Acalabrutinib – Calquence®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Acalabrutinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Acalabrutinib | 1420477-60-6 | C26-H23-N7-O2
Ibrutinib | 936563-96-1 | C25-H24-N6-O2

## ANNOTATED BIBLIOGRAPHY

References updated: 21 March 2021

Abbreviations: BTK, Bruton’s tyrosine kinase; CLL, chronic lymphocytic leukemia; EGFR, epidermal growth factor receptor.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase receptor inhibitors).
DeLeve LD. Kinase inhibitors. Gefitinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, p. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents, does not discuss acalabrutinib or ibrutinib).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2017/210259Orig1s000MultidisciplineR.pdf (FDA scientific review of the NDA for safety and efficacy of acalabrutinib, October 26, 2017).
Ponader S, Burger JA. (2014). Bruton's tyrosine kinase: from X-linked agammaglobulinemia toward targeted therapy for B-cell malignancies. J Clin Oncol. (History of discovery of X-linked agammaglobulinemia, identification of Bruton’s tyrosine kinase [BTK] as its cause, elucidation of role of BTK in the pathway of B cell activation, and development of BTK inhibitors including ibrutinib).
de Jésus Ngoma P, Kabamba B, Dahlqvist G, Sempoux C, Lanthier N, Shindano T, Van Den Neste E, et al. (2015). Occult HBV reactivation induced by ibrutinib treatment: a case report. Acta Gastroenterol Belg. (80 year old man with chronic lymphocytic leukemia [CLL] and anti-HBc without HBsAg in serum [HBV DNA 420 IU/mL] developed reactivation of hepatitis B 5 months after starting ibrutinib [HBsAg positive, HBV DNA 23 million IU/mL, ALT rising to 103 U/L], improving on entecavir therapy with decline in HBV DNA and ALT levels, but HBsAg remained positive).
Byrd JC, Harrington B, O'Brien S, Jones JA, Schuh A, Devereux S, Chaves J, et al. (2016). Acalabrutinib (ACP-196) in relapsed chronic lymphocytic leukemia. N Engl J Med. (Among 61 patients with relapsed CLL treated with acalabrutinib [100 to 400 mg daily], the overall response rate was 95% and common adverse events included headache [43%], diarrhea [39%], fever [23%], fatigue [21%], hypertension [20%], nausea [20%] and weight loss [26%]; no mention of ALT elevations or hepatotoxicity).
Wu J, Zhang M, Liu D. (2016). Acalabrutinib (ACP-196): a selective second-generation BTK inhibitor. J Hematol Oncol. (Review of the mechanism of action, preclinical evaluation and status of clinical studies of acalabrutinib mentions its specificity for BTK and lack of effect on epidermal growth factor receptor [EGFR] and other tyrosine kinases).
Herishanu Y, Katchman H, Polliack A. (2017). Severe hepatitis B virus reactivation related to ibrutinib monotherapy. Ann Hematol. (79 year old man with CLL and anti-HBc without HBsAg in serum developed reactivation of hepatitis B 12 months after starting ibrutinib [HBsAg positive, HBV DNA 1.9 million IU/mL, ALT 987 U/L, direct bilirubin 14.2 mg/dL], resolving with tenofovir therapy and later tolerated restarting ibrutinib while continuing tenofovir to prevent reactivation).
Wang M, Rule S, Zinzani PL, Goy A, Casasnovas O, Smith SD, Damaj G, et al. (2018). Acalabrutinib in relapsed or refractory mantle cell lymphoma (ACE-LY-004): a single-arm, multicentre, phase 2 trial. Lancet. (Among 124 patients with relapsed or refractory mantle cell lymphoma treated with acalabrutinib, 81% had an objective response which was complete in 40%, and the most common side effects were headache, diarrhea, fatigue and myalgia; no mention of ALT elevations or hepatotoxicity).
Markham A, Dhillon S. (2018). Acalabrutinib: first global approval. Drugs. (Review of the history of development, mechanism of action, clinical efficacy and safety of acalabrutinib, mentions that reactivation of hepatitis B occurred in one of 610 subjects treated with acalabrutinib, but does not mention ALT elevations or hepatotoxicity).
(2018). In brief: Acalabrutinib (Calquence) for mantle cell lymphoma. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy and safety of acalabrutinib shortly after its approval for use in the US mentions serious adverse events of neutropenia, anemia, pneumonia and hemorrhage; no mention of ALT elevations or hepatotoxicity).
Awan FT, Schuh A, Brown JR, Furman RR, Pagel JM, Hillmen P, Stephens DM, et al. (2019). Acalabrutinib monotherapy in patients with chronic lymphocytic leukemia who are intolerant to ibrutinib. Blood Adv. (Among 33 patients with CLL who were intolerant to ibrutinib therapy and were then treated with acalabrutinib, recurrence of adverse events was uncommon and usually mild; no mention of hepatic adverse events).
Owen RG, McCarthy H, Rule S, D'Sa S, Thomas SK, Tournilhac O, Forconi F, et al. (2020). Acalabrutinib monotherapy in patients with Waldenström macroglobulinemia: a single-arm, multicentre, phase 2 study. Lancet Haematol. (Among 106 patients with Waldenström macroglobulinemia treated with acalabrutinib, overall response rates were 93% while adverse events were frequent including grade 3 neutropenia [16%], pneumonia [7%], atrial fibrillation [1%], bleeding [7%], ALT elevations above 5 times ULN [5%] which led to early drug discontinuation in one patient but was not associated with clinically apparent liver injury).
Sharman JP, Egyed M, Jurczak W, Skarbnik A, Pagel JM, Flinn IW, Kamdar M, et al. (2020). Acalabrutinib with or without obinutuzumab versus chlorambucil and obinutuzumab for treatment-naive chronic lymphocytic leukaemia (ELEVATE TN): a randomised, controlled, phase 3 trial. Lancet. (Among 535 patients with previously untreated CLL treated with acalabrutinib alone (A), acalabrutinib and obinutuzumab (AO) or obinutuzumab with chlorambucil (OC), 24 month progression-free survival rates were higher with AO [93%] and A [87%] than with OC [47%], while adverse events with acalabrutinib included neutropenia [10%], atrial fibrillation [4%], hypertension [2%], serious bleeding [2%] and secondary malignancies [9%], while reactivation of hepatitis B arose in 3 patients on AO but none on A alone or OC; rates of ALT elevations were not reported).
Ghia P, Pluta A, Wach M, Lysak D, Kozak T, Simkovic M, et al. (2020). ASCEND: phase III, randomized trial of acalabrutinib versus idelalisib plus rituximab or bendamustine plus rituximab in relapsed or refractory chronic lymphocytic leukemia. J Clin Oncol. (Among 310 patients with refractory or relapsed CLL treated with acalabrutinib or standard regimens, the 12 month progression-free survival rate was greater with acalabrutinib [88% vs 68%] and adverse event rates were somewhat less [94% vs 99%] including severe adverse events [45% v 86%] and ALT elevations [1.9% vs 12%]).
Lipsky A, Lamanna N. (2020). Managing toxicities of Bruton tyrosine kinase inhibitors. Hematology Am Soc Hematol Educ Program. (Review of the frequency, severity, cause and management of adverse side effects of Bruton tyrosine kinase inhibitors including acalabrutinib focusing upon cardiac arrhythmias, bleeding risk, infections, hypertension, diarrhea, fatigue, arthralgias, myalgias, cytopenias, skin reactions and headache; no specific discussion of hepatotoxicity).
Delgado J, Josephson F, Camarero J, Garcia-Ochoa B, Lopez-Anglada L, Prieto-Fernandez C, van Hennik PB, et al. (2021). EMA review of acalabrutinib for the treatment of adult patients with chronic lymphocytic leukemia. Oncologist. (Summary of the European Medicines Administration review of acalabrutinib which led to its approval in Europe for the therapy for CLL, adverse events included headache, diarrhea, neutropenia, nausea and infections and “hepatotoxicity” in 11% of cases in one study).

## OTHER REFERENCE LINKS

1 Recent References on Acalabrutinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Acalabrutinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Acalabrutinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Acalabrutinib)